# Fosfomycin

## OVERVIEW

### Introduction

Fosfomycin is an orally available, broad spectrum antibiotic used largely for treatment of uncomplicated urinary tract infections. Fosfomycin is associated with a low rate of transient serum enzyme during therapy and with rare cases of clinically apparent acute liver injury with jaundice.

### Background

Fosfomycin (fos' foe mye. sin) is an oral, broad spectrum bactericidal antibiotic that is typically used as a single, large oral dose to treat acute cystitis. Fosfomycin (also known as phosphomycin) is a natural product of Streptomyces fradiae that acts by inactivation of a bacterial enzyme necessary for cell wall synthesis. Fosfomycin has a unique structure (an analogue of phosphoenolpyruvate) and is structurally unrelated to other antibiotics. It has activity against both gram-positive and gram-negative bacteria and is excreted largely unchanged and in its active form in the urine, making it useful for treatment of urinary tract infections. Antibacterial resistance is, however, frequent with prolonged use. Fosfomycin was approved for use in the United States in 1997 and current indications are for uncomplicated urinary tract infections caused by susceptible organisms. Fosfomycin is available under the commercial name Monurol in a sachet of 3 grams and is recommended as a single dose. Intravenous formulations of fosfomycin have been used in combination with carbapenems or aminoglycosides as therapy of multidrug resistant bacterial organisms such as methicillin-resistant Staphyloccocus aureus (MRSA), but it has yet to be approved for this use in the United States. The intravenous formulation is generally given in 1 to 2 gram amounts every 6 hours for 3 to 28 days. Oral fosfomycin is well tolerated; common side effects may include diarrhea, nausea, headache and fungal vaginitis. Rare, but potentially serious adverse events include allergic reactions, anaphylaxis and toxic megacolon.

### Hepatotoxicity

Serum aminotransferase elevations occur in a small proportion of patients after a single oral dose of fosfomycin (1-2%), but at rates similar to those with comparator antibiotics. Nevertheless, serum enzyme elevations are mentioned as potential adverse events in the product label for fosfomycin. In addition, a small number of cases of clinically apparent liver injury attributed to fosfomycin have been published. The time to onset has been short, within one week of a single oral dose or within the first week of intravenous therapy, and the pattern of liver enzyme elevations has been mixed or hepatocellular. The injury has typically been mild and self-limited, and no cases of fatal acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been convincingly linked to fosfomycin. The number of cases described has been too few to establish a typical clinical pattern, but immunoallergic features and autoimmune markers appear to be uncommon.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury due to fosfomycin is unknown, but is likely to be immunologically mediated. Fosfomycin has minimal hepatic metabolism (mostly glucuronidation), and drug-drug interactions with it are not expected.

### Outcome and Management

The severity of the liver injury linked to fosfomycin has ranged from transient, asymptomatic serum enzyme elevations to clinically apparent hepatitis. Severe but not fatal instances of acute hepatitis have been reported. In one publication, reexposure to fosfomycin after clinically apparent liver injury led to a rapid recurrence. Fosfomycin has a unique chemical structure unlike other antibiotics, and there is evidence for cross sensitivity to hepatic injury between fosfomycin and other antimicrobial agents.

Drug Class: Antiinfective Agents

## CASE REPORT

### Case 1. Acute hepatitis attributed to fosfomycin.

[Modified from: Matsumori A, Yoneda S, Kobayashi Y, Takeda K, Andoh M, Yamane Y, Nishimura K, et al. [A case of acute severe hepatitis induced by fosfomycin]. Nihon Shokakibyo Gakkai Zasshi 2005; 102: 1207-11. Japanese. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16180681)]

A 30 year old, previously healthy man with an upper respiratory infection developed fever, fatigue, and jaundice a few days after a single, oral dose of fosfomycin. He had no history of liver disease, alcohol abuse or drug allergies. He was not taking other medications except for cold remedies. He had fever, but no rash or lymphadenopathy. Laboratory tests showed a total bilirubin of 6.5 mg/dL (direct 3.5 mg/dL), ALT 558 U/L, AST 442 U/L, alkaline phosphatase 649 U/L, GGT 192 U/L and a prothrombin index of 44% (roughly equivalent to an INR of 1.7). He was admitted for observation and management (Table). Tests for hepatitis A, B and C were negative as were tests for CMV and EBV infection. ANA and AMA were negative and IgG levels were minimally elevated (1714 mg/dL). An abdominal ultrasound and enhanced CT showed evidence of severe liver necrosis with atrophy. Within the next few days, he developed asterixis with a worsening of prothrombin time and hyperammonemia (112 μg/dL). He was treated with plasma exchange given infusions of glucagon and insulin, whereupon he began to improve. A liver biopsy done 6 weeks after presentation showed spotty necrosis, inflammation and regeneration. He was discharged after 42 days in the hospital. All laboratory tests were normal when he was seen in follow up, 4 months after onset.

#### Key Points

Medication: | Fosfomycin, single oral dose
Pattern: | Mixed (R=~2.8)
Severity: | 4+ (jaundice, hospitalization and features of hepatic failure)
Latency: | 3 days
Recovery: | Within 4 months
Other medications: | Over-the-counter cold remedies

#### Laboratory Values

Time After Starting/Stopping | ALT* (U/L) | Prothrombin Index* | Bilirubin* (mg/dL) | Comments
3 days | 558 | 44% | 6.5 | Admission
6 days | 540 | 40% | 6.5 | Plasma exchange
8 days | 480 | 35% | 6.4 | Plasma exchange
11 days | 220 | 30% | 3.5 | Plasma exchange
13 days | 130 | 33% | 3.0
16 days | 160 | 37% | 3.8
20 days | 150 | 45% | 2.0
30 days | 100 | 75% | 1.4
42 days | 50 | 80% | 1.2 | Liver biopsy, discharged
4 months | 25 | 95% | 0.8
Normal | Not Given | >80% | <1.2

*Values estimated from Figure 3.

#### Comment

A young man developed a severe hepatitis a few days after receipt of a single, large oral dose of fosfomycin for a suspected upper respiratory infection. The pattern of liver enzyme elevations was "mixed", but the course resembled acute liver failure. Other causes of liver disease were adequately ruled out, although tests for hepatitis E and a few rare opportunistic viral infections were not done. Evidence of hepatic failure included prolongation of prothrombin time, hyperammonemia, asterixis and CT and ultrasound evidence of severe hepatic necrosis. The few other reported cases of clinically apparent liver injury from fosfomycin have been self-limited, with mild jaundice and a hepatocellular pattern of serum enzyme elevations. Fosfomycin has been used extensively abroad, in Europe and Asia, but has had limited use in the United States. As might be expected, cases of drug induced liver injury from fosfomycin have been reported from Japan, China and Europe, but not the United States. [Help in the translation of this case report was kindly provided by Dr. Saturo Saito.]

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fosfomycin – Monurol®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=fluoxetine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fosfomycin | 23155-02-4 | C3-H7-O4-P | chemical structure for Fosfomycin

## ANNOTATED BIBLIOGRAPHY

References updated: 06 February 2018

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of hepatotoxicity of antibiotics published in 1999 does not mention fosfomycin).
Moseley RH. Antibacterial and Antifungal Agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. p. 463-81. (Review of hepatotoxicity of antibacterial medications; does not discuss fosfomycin).
de Jong Z, Pontonnier F, Plante P. Single-dose fosfomycin trometamol (Monuril) versus multiple-dose norfloxacin: results of a multicenter study in females with uncomplicated lower urinary tract infections. Urol Int 1991; 46: 344-8. (Among 63 patients given fosfomycin or norfloxacin for uncomplicated urinary tract infections, efficacy was similar, but side effects were fewer and of shorter duration with fosfomycin; one patient on norfloxacin, but none on fosfomycin had "change in hepatic function"). 1926651
Van Pienbroek E, Hermans J, Kaptein AA, Mulder JD. Fosfomycin trometamol in a single dose versus seven days nitrofurantoin in the treatment of acute uncomplicated urinary tract infections in women. Pharm World Sci 1993; 15: 257-62. (Among 231 women with urinary tract infections managed in general practices in the Netherlands who were treated with a single dose of fosfomycin or 7 days of nitrofurantoin, clinical cure rates were similar and side effects were generally mild and self-limited; no mention of ALT elevations or hepatotoxicity). 8298585
Mayama T, Yokota M, Shimatani I, Ohyagi H. Analysis of oral fosfomycin calcium (Fosmicin) side-effects after marketing. Int J Clin Pharmacol Ther Toxicol 1993; 31: 77-82. (Analysis of spontaneous reports of adverse events associated with the first six years of clinical use of fosfomycin capsules from 28,238 patients in Japan found 2.9% frequency of gastrointestinal symptoms and 0.2% rate of "disorder of liver and bile duct", but no case associated with jaundice). 8458680
Elhanan G, Tabenkin H, Yahalom R, Raz R. Single-dose fosfomycin trometamol versus 5-day cephalexin regimen for treatment of uncomplicated lower urinary tract infections in women. Antimicrob Agents Chemother 1994; 38: 2612-4. (Among 112 women with urinary tract infections treated with either cephalexin or fosfomycin, efficacy was similar in the two groups and there were no significant adverse events attributed to fosfomycin). 7872756
Patel SS, Balfour JA, Bryson HM. Fosfomycin tromethamine. A review of its antibacterial activity, pharmacokinetic properties and therapeutic efficacy as a single-dose oral treatment for acute uncomplicated lower urinary tract infections. Drugs 1997; 53: 637-56. (Review of the mechanism of action, efficacy and safety of fosfomycin mentions that reported serious adverse events included angioedema, asthma, cholestatic jaundice, hepatic necrosis, toxic megacolon and optic neuritis). 9098664
Fosfomycin for urinary tract infections. Med Lett Drugs Ther 1997; 39 (1005): 66-8. (Concise review of the activity, efficacy, side effects and costs of fosfomycin for urinary tract infections shortly after its approval for this use in the US; no mention of hepatotoxicity or ALT elevations). 9255237
Minassian MA, Lewis DA, Chattopadhyay D, Bovill B, Duckworth GJ, Williams JD. A comparison between single-dose fosfomycin trometamol (Monuril) and a 5-day course of trimethoprim in the treatment of uncomplicated lower urinary tract infection in women. Int J Antimicrob Agents 1998; 10: 39-47. (Among 547 women with urinary tract infections treated by general practitioners with either a single oral dose of fosfomycin or a 5 day course of trimethoprim, efficacy was similar; side effects were not discussed). 9624542
Stein GE. Comparison of single-dose fosfomycin and a 7-day course of nitrofurantoin in female patients with uncomplicated urinary tract infection. Clin Ther 1999; 21: 1864-72. (Among 749 women with urinary tract infections treated with a single oral dose of fosfomycin or a 5 day course of nitrofurantoin, response rates and adverse event rates were similar and there were "no clinically significant changes in biochemical or hematologic values"). 10890258
Durupt S, Josserand RN, Sibille M, Durieu I. Acute, recurrent fosfomycin-induced liver toxicity in an adult patient with cystic fibrosis. Scand J Infect Dis 2001; 33: 391-2. (30 year old woman with cystic fibrosis developed abdominal pain 4 days after starting intravenous fosfomycin [12 g daily] and imipenem [bilirubin not given, ALT 921 U/L, GGT 214 U/L], which resolved a month after antibiotics were stopped and recurred 3 days after starting cefepim and fosfomycin [ALT 163 U/L, GGT 79 U/L], resolving within 1 week of stopping and recurring with a third course of fosfomycin). 11440232
Matsumori A, Yoneda S, Kobayashi Y, Takeda K, Andoh M, Yamane Y, Nishimura K, et al. [A case of acute severe hepatitis induced by fosfomycin]. Nihon Shokakibyo Gakkai Zasshi 2005; 102: 1207-11. Japanese. (30 year old man with an upper respiratory tract infection developed jaundice 3 days after a single oral dose of fosfomycin [bilirubin 6.5 mg/dL, ALT 558 U/L, Alk P 649 U/L, prothrombin index 44%], with a severe course, but resolving within 4 months: Case 1). 16180681
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US between 2004 and 2008, more than 100 agents were implicated and the most commonly implicated class of agents was antibiotics, but no case was attributed to fosfomycin). 18955056
Wang YP, Shi B, Chen YX, Xu J, Jiang CF, Xie WF. Drug-induced liver disease: an 8-year study of patients from one gastroenterological department. J Dig Dis 2009; 10: 195-200. (30 cases of drug induced liver injury were seen at a single large hospital in Shanghai between 2000 and 2007, including one case in a 50 year old man who developed mild hepatitis [bilirubin 2.5 mg/dL, ALT 12.8 times and Alk P 1.9 times ULN] within 3 days of starting fosfomycin). 19659787
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to fosfomycin). 20949552
Falagas ME, Vouloumanou EK, Togias AG, Karadima M, Kapaskelis AM, Rafailidis PI, Athanasiou S. Fosfomycin versus other antibiotics for the treatment of cystitis: a meta-analysis of randomized controlled trials. J Antimicrob Chemother 2010; 65: 1862-77. (Systematic review of 27 controlled trials of fosfomycin for urinary tract infections mentions diarrhea and headache as complications, but does not mention ALT elevations or hepatotoxicity). 20587612
Qiao LD, Zheng B, Chen S, Yang Y, Zhang K, Guo HF, Yang B, et al. Evaluation of three-dose fosfomycin tromethamine in the treatment of patients with urinary tract infections: an uncontrolled, open-label, multicentre study. BMJ Open 2013; 3: e004157. (Among 356 Chinese patients with acute cystitis who received three 3 g doses of fosfomycin, side effects included diarrhea [5%]; no mention of ALT elevations or hepatotoxicity). 24309172
Del RíA, Gasch O, Moreno A, Peñ, Cuquet J, Soy D, Mestres CA, et al.; FOSIMI Investigators. Efficacy and safety of fosfomycin plus imipenem as rescue therapy for complicated bacteremia and endocarditis due to methicillin-resistant Staphylococcus aureus: A multicenter clinical trial. Clin Infect Dis 2014; 59: 1105-12. (Among 16 patients with complicated MRSA infections treated with the combination of imipenem and fosfomycin [2 g intravenously every 6 hours for 4 to 75 days], blood cultures were negative at 72 hours in all patients and no breakthrough infections occurred; side effects included sodium overload in 3 patients and leukopenia in one; no mention of ALT elevations or hepatotoxicity). 25048851
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 cases [36%] were attributed to antibiotics, but none to fosfomycin).
Iarikov D, Wassel R, Farley J, Nambiar S. Adverse Events Associated with Fosfomycin Use: Review of the literature and analyses of the FDA adverse event reporting System database. Infect Dis Ther 2015; 4: 433-58. (Systematic review of the literature and the FDA reporting sytem for adverse events related to fosfomycin, found ALT elevations occurring in similar proportions of patients treated with fosfomycin (oral or iv) as with comparator antibiotics [<1% vs <1%] and that only 5 instances of hepatitis in patients receiving fosfomycin have been reported to the FDA, suggesting that liver injury is quite rare even with parenteral therapy). 26437630
Matthews PC, Barrett LK, Warren S, Stoesser N, Snelling M, Scarborough M, Jones N. Oral fosfomycin for treatment of urinary tract infection: a retrospective cohort study. BMC Infect Dis 2016; 16: 556. (Among 75 patients treated for 151 episodes of urinary tract infections, adverse events were uncommon; no mention of ALT elevations or hepatotoxicity). 27729016
Jacobson S, Junco Noa L, Ahmed S, Wallace MR. Efficacy and wafety of oral fosfomycin for urinary tract infections in hospitalized patients. Antimicrob Agents Chemother 2016; 60: 1952. (Among 71 patients treated with oral fosfomycin for urinary tract infections, cure rate was 83% and adverse event rate 4%, which were mostly nausea and vomiting; no mention of ALT elevations or hepatotoxicity). 26921414

## OTHER REFERENCE LINKS

1. Recent References on Fosfomycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(fluoxetine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fosfomycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluoxetine)